# Lansoprazole

## OVERVIEW

### Introduction

Lansoprazole is a proton pump inhibitor (PPI) and a potent inhibitor of gastric acidity which is widely used in the therapy of gastroesophageal reflux and peptic ulcer disease. Dexlansoprazole is an isomer of lansoprazole that has a similar spectrum of activity and toxicities. Lansoprazole therapy is associated with a low rate of transient and asymptomatic serum aminotransferase elevations and is a reported, but very rare cause of clinically apparent liver injury.

### Background

Lansoprazole (lan soe' pra zole), like other PPIs, binds to and inactivates the hydrogen/ potassium (H+/K+) ATPase of gastric parietal cells, causing inhibition of the proton pump that transports H+ into the gastric lumen, the final common step in gastric acid production. Lansoprazole is a prodrug and is converted to the active form in the acidic secretory canaliculi of parietal cells. Because the inhibition is irreversible, acid secretion is suppressed for 24 to 48 hours, until new proton pump molecules have been synthesized and transported to the cell membrane. Lansoprazole was the second PPI approved for use in the United States (1995) and dexlansoprazole, a stereoisomer, was approved for use in 2009. Lansoprazole is available in 15 and 30 mg delayed release capsules and tablets, as well as granules for oral suspension and in vials for parenteral use under the brand name of Prevacid. Over-the-counter formulations have also become available. The typical dose in adults with peptic ulcer disease is 15 mg daily for 4 to 8 weeks and similar dose chronically for maintenance therapy. Higher doses are recommended for more severe cases of gastrointestinal reflux and peptic ulcer disease, and doses of up to 120 mg daily for Zollinger-Ellison syndrome. Combinations of lansoprazole with antibiotics for 10 to 14 days are effective and recommended for eradication of H. pylori infection. Dexlansoprazole is available by prescription only in capsules of 30 or 60 mg under the brand name Dexilant. The recommended dose of dexlansoprazole is 30 to 60 mg once daily. Both lansoprazole and dexlanscprazole are very well tolerated. Side effects are uncommon and usually mild: they can include diarrhea, nausea, vomiting, abdominal discomfort, flatulence, skin rash, headaches and dizziness. Severe adverse events are rare but can include hypersensitivity reactions. Long-term use may be associated with bone fractures, acute interstitial nephritis, lupus erythematosus, vitamin B12 deficiency and hypomagnesemia.

### Hepatotoxicity

Despite its wide use, lansoprazole has only rarely been associated with hepatic injury. In large scale, long term trials of lansoprazole, serum ALT elevations have occurred in less than 1% of patients and at rates similar to those that occur with placebo or comparator drugs. Only a small number of cases of clinically apparent liver disease due to lansoprazole or dexlansoprazole have been published and most have been anicteric and mild. In most instances, the time to onset was within 2 to 4 weeks and the pattern of enzyme elevations was hepatocellular or mixed. Hypersensitivity reactions with fever, rash and eosinophilia have been described due to dexlansoprazole and lansoprazole, and these reactions may be accompanied by minor serum enzyme elevations and thus qualify for DRESS syndrome (drug-rash with eosinophilia and systemic symptoms). Autoantibody formation is rare. Recovery is usually rapid (within a month) and complete upon stopping lansoprazole. Recurrence on reexposures has been reported.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

Several features of the hepatic injury with lansoprazole suggest a hypersensitivity reaction, but may merely reflect altered metabolism or acute toxicity of a metabolic byproduct. Lansoprazole is metabolized by the hepatic P450 system, but has little effect on the activity of the drug-metabolizing enzymes.

### Outcome and Management

The mild and asymptomatic elevations in serum aminotransferase that have been observed during lansoprazole therapy are usually transient and usually resolve even without dose modification. Clinically apparent liver injury due to dexlansoprazole and lansoprazole, however, generally calls for prompt withdrawal of the agent. Severe injury is uncommon and most cases resolve promptly upon withdrawal. Cases of acute liver failure due proton pump inhibitors have been described, but they are exceedingly rare. There is no information about cross reactivity among the various PPIs after lansoprazole hepatotoxicity, but the PPIs all share a benzimidazole structure, and caution should be used in attempting to reintroduce another PPI after clinically apparent PPI-associated hepatic injury.

Drug Class: Antiulcer Agents

Other Drugs in the Subclass, Proton Pump Inhibitors: Esomeprazole, Omeprazole, Pantoprazole, Rabeprazole

## CASE REPORT

### Case 1. Acute hepatitis attributed to lansoprazole.

[Modified from: Viana de Miguel C, Alvarez García M, Sánchez Sánchez A, Carvajal García-Pando A. [Lansoprazole-induced hepatitis]. Med Clin (Barc) 1997; 108: 599. Spanish. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9280798)]

A 62 year old man with gastroesophageal reflux disease developed fatigue and jaundice 25 days after switching from omeprazole (20 mg daily for 3 months) to lansoprazole (30 mg daily). He had no history of drug reactions, liver disease, jaundice, alcohol abuse or risk factors for viral hepatitis. Laboratory testing showed marked elevations in serum bilirubin (26.0 mg/dL) and aminotransferase levels (ALT 1498 U/L, AST 952 U/L), and mild elevations in alkaline phosphatase (346 U/L: normal values not given). Tests for hepatitis A, B, and C were negative and abdominal ultrasound showed a single gallstone without evidence of biliary obstruction. A liver biopsy was compatible with acute toxic hepatitis. Lansoprazole was discontinued promptly upon admission and he improved rapidly, all liver tests being normal when he was seen 50 days later.

#### Key Points

Medication: | Lansoprazole (30 mg daily)
Pattern: | Hepatocellular (R=~12.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 25 days
Recovery: | 50 days
Other medications: | None mentioned

#### Comment

This brief letter to the editor describes one of the few cases of lansoprazole associated liver injury in the literature. The onset of injury was within 4 weeks of starting lansoprazole, which is typical of proton-pump inhibitor associated acute liver injury, as was the hepatocellular pattern of serum enzyme elevations. Symptoms of hypersensitivity were not mentioned nor were autoantibody test results given, but the pattern otherwise resembles the clinically apparent liver injury associated with PPIs. Interestingly, this patient had tolerated omeprazole therapy for 3 months without problems, suggesting that there is little cross reactivity to hepatic injury among the proton pump inhibitors. Unfortunately, this cannot be assumed for all such agents and caution should be used in restarting another proton pump inhibitor after clinical apparent liver injury due to another.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lansoprazole – Generic, Prevacid®

DRUG CLASS

Antiulcer Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lansoprazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lansoprazole | 103577-45-3 | C16-H14-F3-N3-O2-S | Lansoprazole structure
Dexlansoprazole | 138530-94-6 | C16-H14-F3-N3-O2-S | Dexlansoprazole structure

## ANNOTATED BIBLIOGRAPHY and Dexlansoprazole

References updated: 15 April 2019

Zimmerman HJ. Proton pump inhibitors. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 720-1. (Expert review of hepatotoxicity published in 1999 states that aminotransferase elevations occur in ~1% of PPI treated patients, but only 1 case of acute liver injury has been reported with omeprazole, none with the more recently released lansoprazole and pantoprazole).
Sharkey KA, McNaughton WK. Pharmacotherapy of gastric acidity, peptic ulcers, and gastroesophageal reflux disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 909-20. (Textbook of pharmacology and therapeutics).
Arnold R. Safety of proton pump inhibitors - an overview. Aliment Pharmacol Ther 1994; 8 Suppl 1: 65-70. (Side effects of PPIs are uncommon and no more frequent than with cimetidine and ranitidine; "Omeprazole had no clinically relevant effects on laboratory values including...liver function"). 8180297
Viana de Miguel C, Alvarez García M, Sánchez Sánchez A, Carvajal García-Pando A.. [Lansoprazole-induced hepatitis]. Med Clin (Barc) 1997; 108: 599. Spanish. (62 year old man developed fatigue and jaundice 25 days after switching from omeprazole [given for 3 months] to lansoprazole [bilirubin 26.0 mg/dL, ALT 1498 U/L, Alk P 346 U/L], biopsy showed toxic hepatitis, resolving in 50 days: Case 1). 9280798
Baudot S, Milpied-Homsi B, Andres P, Poirier Y, Larousse C. [Lansoprazole hypersensitivity syndrome]. Therapie 1999; 54: 491-3. French. (41 year old developed rash 4 weeks after switching from omeprazole to lansoprazole, followed a week later by generalized erythema, fever, fatigue, and lymphadenopathy, with ALT 4 times ULN and eosinophilia [bilirubin levels not given]; PPIs were stopped and high dose corticosteroids started, prednisone therapy lasting 8 months). 10667118
Reilly JP. Safety profile of the proton-pump inhibitors. Am J Health Syst Pharm 1999; 56 (23 Suppl 4): S11-7. (Review of side effects of proton pump inhibitors including long term tolerance). 10597119
Martin RM, Dunn NR, Freemantle S, Shakir S. The rates of common adverse events reported during treatment with proton pump inhibitors used in general practice in England: cohort studies. Br J Clin Pharmacol 2000; 50: 366-72. (Prescription event monitoring of common side effects of omeprazole, lansoprazole and pantoprazole from the UK found low rates of diarrhea [0.18-0.39/1000 days], abdominal pain [0.17-.21], nausea [0.16-0.22] and headache [0.10-0.17]; no analysis of liver toxicities). 11012560
Matheson AJ, Jarvis B. Lansoprazole: an update of its place in the management of acid-related disorders. Drugs 2001; 61: 1801-33. (Review of pharmacology, clinical efficacy and safety of lansoprazole; in studies of more than 30,000 patients, most common side effects are diarrhea, nausea, headache and abdominal pain; no discussion of ALT elevations or hepatotoxicity). 11693467
García-Cortés M, Lucena MI, Andrade RJ, Romero-Gómez M, Fernández MC. Lansoprazole-induced hepatic dysfunction. Ann Pharmacother 2003; 37: 1731. (Two cases of enzyme elevations without jaundice [one symptomatic] arising in 33 and 47 year olds, 20 and unknown days after starting lansoprazole [bilirubin 1.0 and 0.96 mg/dL, ALT 228 and 246 U/L, Alk P 110 and 361 U/L], resolving in 1-3 months; the asymptomatic patient restarted lansoprazole and had recurrence of ALT elevations). 14626292
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to an H2 blocker or proton pump inhibitor). 15390328
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person years]; 3 cases were attributed to cimetidine for an odds ratio of 2.0 compared to controls [n=5000] which was not statistically significant; PPIs not mentioned). 15206996
Heaton NR, Edmonds EV, Francis ND, Bunker CB, Bowling JC, Morar N. Fatal toxic epidermal necrolysis due to lansoprazole. Clin Exp Dermatol 2004; 29: 612-3. (72 year old developed toxic epidermal necrolysis one week after starting lansoprazole with fever, heart failure and respiratory arrest; had a history of skin rash after receiving lansoprazole in the past; no liver tests reported). 15550134
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002: 103 cases identified as highly probable, probable or possible, one case attributed to ranitidine and one to omeprazole, but none to the other antiulcer agents). 16165719
Severino G, Chillotti C, De Lisa R, Del Zompo M, Ardau R. Adverse reactions during imatinib and lansoprazole treatment in gastrointestinal stromal tumors. Ann Pharmacother 2005; 39: 162-4. (60 year old with gastrointestinal stromal tumors on imatinib therapy developed facial edema and Stevens Johnson syndrome 10 days after starting lansoprazole for dyspepsia; she recovered upon stopping, but rash recurred when patient restarted both medications 2 months later). 15546944
Salgueiro E, Rubio T, Hidalgo A, Manso G. Safety profile of proton pump inhibitors according to the spontaneous reports of suspected adverse reactions. Int J Clin Pharmacol Ther 2006; 44: 548-56. (Analysis of PPI related reports to Spanish Pharmacovigilance Database during 2004 found 58 reports of liver injury from omeprazole [n=36], lansoprazole [7], pantoprazole [12], rabeprazole [2], and esomeprazole [1], correlating somewhat with relative number of prescriptions; 82% were taking other medications; most "evolved to recovery"). 17176621
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25:1401-9. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain; 8 were attributed to ranitidine alone [incidence 5.1/100,000 person years] and 5 to omeprazole alone [2.1/100,000]). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 were attributed to ranitidine, none to cimetidine or the proton pump inhibitors). 18955056
Lobera T, Navarro B, Del Pozo MD, González I, Blasco A, Escudero R, Venturini M, Alarcón E. Nine cases of omeprazole allergy: cross-reactivity between proton pump inhibitors. J Investig Allergol Clin Immunol 2009; 19: 57-60. (Among 9 nonatopic women with omeprazole allergy [urticaria, angioedema within 1-4 hours of administration], 8 had positive skin tests to omeprazole and 4 to pantoprazole, but none to lansoprazole; and all but one tolerated treatment with lansoprazole whereas 3 of 3 had recurrence with omeprazole; no mention of liver test results).19274931
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, but none were due to antiulcer medications). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but done were due to lansoprazole or other proton pump inhibitors). 20949552
Zvyaga T, Chang SY, Chen C, Yang Z, Vuppugalla R, Hurley J, Thorndike D, et al. Evaluation of six proton pump inhibitors as inhibitors of various human cytochromes P450: focus on cytochrome P450 2C19. Drug Metab Dispos 2012; 40: 1698-711. (Using human liver microsomes to assess P450 activity, omeprazole and esomeprazole were found to be the most potent inhibitors of 2D9 and most likely to cause clinically relevant drug-drug interactions). 22648560
Fracaroli TS, Miranda LQ, Sodré JL, Chaves M, Gripp A. Toxic epidermal necrolysis induced by lansoprazole*. An Bras Dermatol 2013; 88: 117-20. (23 year old woman developed rash 15 days after starting lansoprazole which spread and desquamated [liver tests not mentioned], resolving within two months after intensive care and IVIG infusions). 23539016
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributable to lansoprazole or any other antiulcer medications). 23419359
Atkins C, Maheswaran T, Rushbrook S, Kamath A. Lansoprazole-induced acute lung and liver injury: a case report. Int J Clin Pharmacol Ther 2014; 52: 1102-4. (61 year old woman developed jaundice and shortness of breath 10 days after starting lansoprazole [bilirubin 7.9 mg/dL, ALT 447 U/L, Alk P 267 U/L] with clinical evidence of hypersensitivity pneumonitis, both the liver and lung injury responding to high doses of prednisone with normal liver tests 1 month later). 25373140
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to lansoprazole or other proton pump inhibitors). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 [0.3%] were attributed to proton pump inhibitors including one each for omeprazole, esomeprazole and lansoprazole). 25754159
Lopez JL, Tayek JA. Voriconazole-induced hepatitis via simvastatin- and lansoprazole-mediated drug interactions: a case report and review of the literature. Drug Metab Dispos 2016; 44: 124-6. (44 year old man with Wegeners granulomatosus and pulmonary aspergillosis on long term voriconazole developed jaundice within 10 days of starting lansoprazole [bilirubin 14 mg/dL, ALT 362 U/L, Alk P 406 U/L], resolving rapidly on stopping but recurrence of jaundice 2 weeks after starting simvastatin [bilirubin 15.4 mg/dL, ALT 893 U/L, Alk P 789 U/L] while still on voriconazole; injury suspected to be due to drug-drug interactions). 26502771
Tsai CF, Chen MH, Wang YP, Chu CJ, Huang YH, Lin HC, Hou MC, Let al. Proton pump inhibitors increase risk for hepatic encephalopathy in patients With cirrhosis in a population study. Gastroenterology 2017; 152: 134-41. (Analysis of the Taiwan National Health Insurance database found a higher rate of proton pump inhibitor use among patients with cirrhosis who developed hepatic encephalopathy [38%: 445 of 1166] compared to a matched group with cirrhosis who did not [rate not provided]; the relative risk was raised for all agents except for rabeprazole). 27639806
Weersink RA, Bouma M, Burger DM, Drenth JPH, Froukje Harkes-Idzinga S, Hunfeld NGM, Metselaar HJ, et al. Safe use of proton pump inhibitors in patients with cirrhosis. Br J Clin Pharmacol 2018 Apr 24. Epub ahead of print]. (Systematic review of 69 publications in the literature suggested that doses of proton pump inhibitors should be reduced in patients with cirrhosis and only omeprazole should be used in those with Child Pugh Class C cirrhosis). 29688583

## OTHER REFERENCE LINKS

1. Recent References on Lansoprazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lansoprazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lansoprazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lansoprazole)